# Lixisenatide

## OVERVIEW

### Introduction

Lixisenatide is a recombinant DNA produced polypeptide analogue of human glucagon-like peptide-1 (GLP-1) which is used in combination with diet and exercise in the therapy of type 2 diabetes, either alone or in combination with other antidiabetic agents. Therapy with lixisenatide has not been associated with serum enzyme elevations or with episodes of clinically apparent liver injury.

### Background

Lixisenatide (lix" i sen' a tide) is a glucagon-like peptide-1 (GLP-1) analogue (also called a GLP-1 receptor agonist) that acts like the native gastrointestinal hormone (incretin) to increase insulin secretion. Lixisenatide, like other GLP-1 analogues, also suppress glucagon production and slows gastric emptying, features that may increase the beneficial effects in type 2 diabetes. Lixisenatide is a recombinant DNA-produced polypeptide that is 44 amino acids in length with a single proline substitution and a modified C-terminus of six lysine molecules that makes it relatively resistant to degradation by dipeptidyl peptidase 4 (DPP4) and extends its half-life allowing for once daily dosing. In multiple preregistration clinical trials, lixisenatide was shown to improve glycemic control and lower HbA1c levels in patients with inadequately controlled type 2 diabetes. Lixisenatide was approved in the United States in 2016 and current indications are for management of glycemic control in adults with type 2 diabetes in combination with diet and exercise, with or without other oral hypoglycemic agents or insulin. Lixisenatide is available under the brand name Adlyxin in multiuse prefilled pens (50 and 100 µg/mL). The recommended starting dose is 10 µg once daily which after 2 weeks can be increased to 20 µg once daily. A fixed combination of lixisenatide (33 µg/mL) with insulin glargine (100 units/mL) is also available under the brand name Soliqua (100/33). Lixisenatide is generally well tolerated, but side effects can be dose limiting and include injection site reactions, diarrhea, nausea, vomiting, dizziness, headache, fatigue and hypoglycemia. Rare adverse events include pancreatitis, severe hypoglycemia, acute renal injury and hypersensitivity reactions.

### Hepatotoxicity

In large clinical trials, serum enzyme elevations were no more common with lixisenatide therapy than with placebo or comparator agents. In pooled safety analyses of more than 5000 patients, ALT elevations above 3 times the upper limit of normal occurred in 0.6% of both lixisenatide and placebo groups and no instances of treatment related clinically apparent liver injury were reported. Since licensure, there have been no published case reports of hepatotoxicity due to lixisenatide and the product label does not list liver injury as an adverse event. Thus, liver injury due to lixisenatide, as with other GLP-1 analogues, must be rare, if it occurs at all.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Lixisenatide is a polypeptide and is metabolized to amino acids by serum and tissue proteases, and is unlikely to have any direct hepatotoxic potential. Lixisenatide acts through the incretin pathway to affect glucose metabolism and, thus, is often grouped with other incretin based antidiabetic mediations such as the DPP-4 inhibitors, sitagliptin, saxagliptin and linagliptin, and other GLP-1 analogues such as exenatide, liraglutide, dulaglutide and albiglutide which are also discussed in LiverTox.

References regarding the hepatotoxicity and safety of lixisenatide are given with the Overview section of the GLP-1 Analogues.

Drug Class: Antidiabetic Agents

Other Drugs in the Subclass, Incretin-Based Drugs, Glucagon-Like Peptide-1 (GLP-1) Analogues: Albiglutide, Dulaglutide, Exenatide, Liraglutide, Semaglutide

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Lixisenatide – Adlyxin®

DRUG CLASS

Antidiabetic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Lixisenatide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Lixisenatide | 320367-13-3 | Protein | Complex Polypeptide

## OTHER REFERENCE LINKS

1. Recent References on Lixisenatide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Lixisenatide/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Lixisenatide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Lixisenatide)